# Doripenem

## OVERVIEW

### Introduction

Doripenem is a broad spectrum carbapenem antibiotic used primarily for the treatment of aerobic gram-negative bacterial infections. Doripenem, like other carbapenems, is associated with transient and asymptomatic elevations in serum enzymes. The carbapenems have also been linked to rare instances of clinically apparent, acute cholestatic liver injury.

### Background

Doripenem (dor" i pen' em) is a broad spectrum beta-lactam antibiotic used predominantly for treatment of severe aerobic gram-negative bacterial infections. Doripenem, like other carbapenems, binds to bacterial penicillin binding proteins and interferes with bacterial cell wall integrity and synthesis. It is a broad spectrum antibiotic with activity against many aerobic and anaerobic gram-positive and gram-negative organisms, including Staphylococcus aureus, Streptococcus pyogenes, Streptococcus agalactiae, viridans group streptococci, Enterococcus faecalis, Pseudomonas aeruginosa, Escherichia coli, Proteus mirabilis, Bacteroides fragilis and Peptostreptococcus species. Doripenem is claimed to have more potent activity against Pseudomonas species than the other carbapenems. Doripenem was approved for use in the United States in 2008, and its use is restricted largely to serious infections in hospitalized patients. Doripenem is indicated for the treatment of severe or complicated intraabdominal, urinary tract and urogenital infections due to susceptible organisms. The recommended dosage is 500 mg given intravenously every 8 hours for 5 to 14 days. It is currently available as Doribax in vials of 250 and 500 mg as a sterile powder for reconstitution. The most common side effects of doripenem are infusion site pain and phlebitis, diarrhea, nausea, rash, pruritus and headache.

### Hepatotoxicity

Mild, transient, asymptomatic elevations in serum aminotransferase levels occur in 1% to 5% of patients receiving parenteral doripenem for 5 to 14 days. These abnormalities are usually self-limited and asymptomatic and rarely above 5 times the upper limit of normal. In the limited period that it has been available, no cases of hepatitis with jaundice have been reported. Nevertheless, several instances of cholestatic jaundice arising during or shortly after therapy have been reported with other carbapenems. The latency to onset has been within 1 to 3 weeks and the pattern of enzyme elevations is usually cholestatic. Immunoallergic features can occur, but autoantibodies are rare. The course is usually self-limiting, but at least one case of vanishing bile duct syndrome related to a carbapenem has been reported. Doripenem and other carbapenems have not been linked to cases of acute liver failure.

Likelihood score: E* (unproven but suspected cause of liver injury).

### Mechanism of Injury

The cause of the mild, transient serum enzyme elevations during doripenem therapy is not known. The cholestatic hepatitis attributed to the carbapenems is probably immunoallergic and resembles the rare clinically apparent liver injury that has been linked to penicillins and cephalosporins.

### Outcome and Management

The liver injury due to the carbapenems is usually mild, asymptomatic and self-limited. Rarely, the carbapenems can cause a clinically apparent acute cholestatic hepatitis that is usually self-limiting and not requiring therapy or intervention. There is little information on possible cross sensitivity to liver injury among the different beta-lactam antibiotics, but patients with clinically apparent liver injury due to doripenem should probably avoid the other carbapenems.

References to the safety and potential hepatotoxicity of doripenem are given in the Overview section on Carbapenems.

Drug Class: Antiinfective Agents, Carbapenems

Other Drugs in the Subclass, Carbapenems: Ertapenem , Imipenem , Meropenem

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Doripenem – Doribax®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Doripenem)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Doripenem | 148016-81-3 | C15-H24-N4-O6-S2 | Doripenem chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Doripenem: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Doripenem/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Doripenem: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Doripenem)